# Bexarotene

## OVERVIEW

### Introduction

Bexarotene is a retinoid analogue that is used to treat the skin manifestations of cutaneous T cell lymphoma (CTCL). Bexarotene therapy is associated with a high rate of serum enzyme elevations and rare instances of clinically apparent acute liver injury.

### Background

Bexarotene (bex ar' oh teen) is a synthetic retinoid analogue and antineoplastic agent that acts through engagement of the retinoid receptors to regulate genes involved in cellular differentiation and growth. Bexarotene is considered a third generation retinoid because it has vitamin A-like activities, but is designed to optimize binding to retinoid X receptors (RXRs) which typically lead to malignant cell apoptosis as opposed to retinoic acid receptors (RARs) which affect cellular differentiation and cell growth. Bexarotene has potent activity on tumor cell lines and has been shown to induce partial or complete remissions in up to half of patients with cutaneous T cell lymphoma (CTCL) refractory to standard therapy. Bexarotene was approved for use in CTCL in 2000 and remains a second line therapy for the cutaneous manifestations of this form of lymphoma. Bexarotene is available as capsules of 75 mg under the brand name Targretin. The recommended dosage is 300 mg/m^2^ daily. Common side effects include hyperlipidemia, headache, weakness, leukopenia, anemia, infection, dry skin, rash and photosensitivity. Rare, but severe adverse events include cataracts, neutropenia, hypothyroidism, pancreatitis and hepatitis. Bexarotene, like other retinoids, is teratogenic and contraindicated during pregnancy and in women who are unable to practice adequate methods of birth control.

### Hepatotoxicity

Serum aminotransferase elevations occur in 5% of patients treated with bexarotene, but the abnormalities are generally mild, transient and not associated with symptoms or jaundice. However, cases of clinically apparent liver injury with jaundice have been reported with bexarotene therapy, some of which were severe and even fatal. Hepatotoxicity appears to be more common with higher doses. The clinical features of the hepatic injury with bexarotene have not been described in any detail and case reports of hepatotoxicity have yet to be published. Nevertheless, the product label mentions hepatotoxicity and recommends prospective monitoring of routine liver tests.

Likelihood score: D (possible but uncommon cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury from bexarotene and other retinoids is unknown, but may relate to their effects in inducing apoptosis. The clinically apparent liver injury from bexarotene is said to have features of hypersensitivity. Bexarotene is extensively metabolized by CYP 3A4 in the liver and is susceptible to multiple drug-drug interactions. Inhibitors of CYP 3A4 such as ketoconazole and clarithromycin can cause increases in bexarotene plasma levels with subsequent toxicity and, therefore, should be avoided.

### Outcome and Management

The severity of the liver injury linked to bexarotene therapy has ranged from mild, transient and asymptomatic serum enzyme elevations to clinically apparent cholestasis to acute liver failure. Bexarotene has not been linked to cases of chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between bexarotene and other retinoids, but some degree of cross sensitivity is likely.

Drug Class: Antineoplastic Agents, Retinoids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bexarotene – Targretin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bexarotene)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bexarotene | 153559-49-0 | C24-H28-O2 | Bexarotene structure
Vitamin A | 68-26-8 | C20-H30-O | Vitamin A structure

## ANNOTATED BIBLIOGRAPHY

References updated: 26 September 2017

Abbreviations: CTCL, cutaneous T cell lymphoma

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; discusses liver injury from retinoids, but not specifically bexarotene).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; bexarotene is not discussed).
Burkhart C, Morrell D, Goldsmith L. Dermatological pharmacology. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp 1803-32. (Textbook of pharmacology and therapeutics).
Bexarotene (Targretin) for cutaneous T-cell lymphoma. Med Lett Drugs Ther 2000; 42 (1075): 31-2. (Concise review of the mechanism of action, clinical efficacy, adverse effects and costs of bexarotene shortly after its approval in the US; mentions that “elevations in aminotransferase concentrations have occurred, and fatal pancreatitis and fatal cholestasis have been reported”). 10788961
Duvic M, Hymes K, Heald P, Breneman D, Martin AG, Myskowski P, Crowley C, et al.; Bexarotene Worldwide Study Group. Bexarotene is effective and safe for treatment of refractory advanced-stage cutaneous T-cell lymphoma: multinational phase II-III trial results. J Clin Oncol 2001; 19: 2456-71. (Among 94 patients with advanced and refractory CTCL treated with bexarotene, clinical responses occurred in 45-55% and side effects were common but usually mild, but led to early termination of therapy in 10%; AST elevations occurred during the first month of treatment in 20% of patients). 11331325
Duvic M, Martin AG, Kim Y, Olsen E, Wood GS, Crowley CA, Yocum RC; Worldwide Bexarotene Study Group. Phase 2 and 3 clinical trial of oral bexarotene (Targretin capsules) for the treatment of refractory or persistent early-stage cutaneous T-cell lymphoma. Arch Dermatol 2001; 137: 581-93. (Among 58 patients with refractory or persistent CTCL treated with bexarotene at different doses, clinical responses occurred in 56% given 300 mg/m^2^ daily, while adverse side effects were common and ALT or AST elevations of 2.5 to 5 times ULN occurred in 10%). 11346336
Esteva FJ, Glaspy J, Baidas S, Laufman L, Hutchins L, Dickler M, Tripathy D, et al. Multicenter phase II study of oral bexarotene for patients with metastatic breast cancer. J Clin Oncol 2003; 21: 999-1006. (Among 145 women with metastatic breast cancer treated with bexarotene, clinical responses were uncommon and usually partial, while adverse events included hypertriglyceridemia [84%], dry skin [34%], weakness [30%] and headache [27%] and two patients [1%] had dose limiting liver test elevations). 12637463
Smit JV, Franssen ME, de Jong EM, Lambert J, Roseeuw DI, De Weert J, Yocum RC, et al. A phase II multicenter clinical trial of systemic bexarotene in psoriasis. J Am Acad Dermatol 2004; 51: 249-56. (Among 50 patients with severe psoriasis treated with bexarotene in 4 doses for 12-24 weeks, clinical responses occurred in 22-52% of patients and adverse events included hypertriglyceridemia [56%], decrease in serum free T4 levels [54%], fatigue [14%], pruritus [14%] and ALT elevations [6%]). 15280844
Kannangara AP, Levitan D, Fleischer AB Jr. Evaluation of the efficacy of the combination of oral bexarotene and methotrexate for the treatment of early stage treatment-refractory cutaneous T-cell lymphoma. J Dermatolog Treat 2009; 20: 169-76. (Among 12 patients with refractory CTCL treated with methotrexate and bexarotene, partial responses occurred in 58%, but one patient who had received 13 g of methotrexate developed grade 3 “liver failure”). 19016373
Väkevä L, Ranki A, Hahtola S. Ten-year experience of bexarotene therapy for cutaneous T-cell lymphoma in Finland. Acta Derm Venereol 2012; 92: 258-63. (Description of 37 Finnish patients with CTCL treated with bexarotene focusing on management of adverse reactions including hypertriglyceridemia and hypothyroidism; mentions that 4 patients [11%] had ALT or AST elevations above 5 times ULN, but the levels returned to normal upon stopping, although they recurred in 1 of 2 patients who restarted therapy at a lower dose). 22678563
Whittaker S, Ortiz P, Dummer R, Ranki A, Hasan B, Meulemans B, Gellrich S, et al. Efficacy and safety of bexarotene combined with psoralen-ultraviolet A (PUVA) compared with PUVA treatment alone in stage IB-IIA mycosis fungoides: final results from the EORTC Cutaneous Lymphoma Task Force phase III randomized clinical trial (NCT00056056). Br J Dermatol 2012; 167: 678-87. (Among 87 patients with mycosis fungoides treated with psoralen with ultraviolet A [PUVA] with or without bexarotene, overall response rates were similar [77% vs 71%], but side effects were greater with the combination including ALT elevations above 5 times ULN [8.7% vs 0%]). 22924950
Lerner V, Miodownik C, Gibel A, Sirota P, Bush I, Elliot H, Benatov R, et al. The retinoid X receptor agonist bexarotene relieves positive symptoms of schizophrenia: a 6-week, randomized, double-blind, placebo-controlled multicenter trial. J Clin Psychiatry 2013; 74: 1224-32. (Among 90 patients with schizophrenia treated with bexarotene [75 mg daily] or placebo for 6 weeks, serum ALT and AST levels did not change significantly in either group). 24434091
Hamada T, Sugaya M, Tokura Y, Ohtsuka M, Tsuboi R, Nagatani T, Tani M, et al. Phase I/II study of the oral retinoid X receptor agonist bexarotene in Japanese patients with cutaneous T-cell lymphomas. J Dermatol 2017; 44: 135-42. (Among 16 patients with cutaneous T cell lymphomas treated with bexarotene for 24 weeks, ALT elevations were reported in 4 [25%] and led to early discontinuation in 1 [6%]. 27543197

## OTHER REFERENCE LINKS

1. Recent References on Bexarotene: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Bexarotene)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bexarotene) Trials on Bexarotene: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bexarotene)